# Rolapitant

## OVERVIEW

### Introduction

Rolapitant is an orally available antiemetic agent that is used to prevent cancer chemotherapy related nausea and vomiting. Rolapitant therapy has not been associated with serum enzyme elevations or with instances of clinically apparent liver injury with jaundice.

### Background

Rolapitant (roe la' pi tant) is a substance P/neurokinin 1 (NK-1) receptor antagonist which has potent and prolonged antiemetic activity. Rolapitant acts as a substance P antagonist blocking the neurokinin 1 (NK1) receptor, which is found in the central nervous system and induces the vomiting reflex when activated by substance P. Rolapitant has been shown to inhibit both acute and delayed nausea and vomiting associated with cancer chemotherapy and surgical procedures and appears to act synergistically with serotonin type 3 (5-HT3) receptor blockers. Because of its delayed half-life, rolapitant is particularly potent in preventing delayed (>24 hours after chemotherapy) nausea and vomiting. Rolapitant was approved for use in the United States in 2015 and current indications are in combination with other antiemetic agents in adults for prevention of delayed chemotherapy associated nausea and vomiting. Rolapitant is available as tablets of 90 mg under the brand name Varubi. The typical adult oral dose is 180 mg within 2 hours of starting each emetogenic chemotherapy cycle, generally in combination with a 5-HT3 receptor blocker, and dexamethasone. It has been used off label to treat postoperative nausea and vomiting. Side effects are uncommon, but can include anorexia, headache, neutropenia, and dizziness. Rolapitant has the potential significant drug-drug interactions with substrates and inducers of cytochrome P450 enzymes.

### Hepatotoxicity

Serum aminotransferase elevations following initial cycles of chemotherapy occurred in less than 2% of rolapitant treated patients and a similar proportion of controls (1.3% vs 1.4% for AST). The aminotransferase elevations were transient, mild-to-moderate in severity, and not associated with symptoms or jaundice. There was no increase in frequency of serum enzyme elevations with subsequent chemotherapy cycles. No cases of clinically apparent liver injury attributable to rolapitant were described in the preregistration clinical trials of this agent, and there have been no cases published in the literature since its approval and more widescale use. Thus, significant liver injury from rolapitant must be rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Rolapitant is metabolized by and inhibits hepatic CYP 2D6 and is a substrate of CYP 3A4 and thus has the potential to cause significant drug-drug interactions with substrates of CYP 2D6 and inducers or inhibitors of CYP 3A4. The mechanism by which rolapitant might cause liver injury is unknown. Rolapitant is generally given as a single, somewhat low oral dose which may account for why it is not associated with significant liver injury.

Drug Class: Gastrointestinal Agents, Antiemetic Agents

Other Drugs in the Subclass, Substance P/Neurokinin-1 Receptor Antagonists: Aprepitant, Fosaprepitant, Fosnetupitant,

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rolapitant – Varubi®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Rolapitant)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Aprepitant | 170729-80-3 | C23-H21-F7-N4-O3
Rolapitant | 552292-08-7 | C25-H26-F6-N2-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 29 February 2024

Zimmerman HJ. Antiemetic and prokinetic compounds. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721. (Expert review of hepatotoxicity published in 1999 before the availability of aprepitant or rolapitant).
Sharkey KA, McNaughton WK. Gastrointestinal motility and water flux, emesis, and biliary and pancreatic disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 921-44. (Textbook of pharmacology and therapeutics).
Gan TJ, Gu J, Singla N, Chung F, Pearman MH, Bergese SD, Habib AS, et al; Rolapitant Investigation Group. Rolapitant for the prevention of postoperative nausea and vomiting: a prospective, double-blinded, placebo-controlled randomized trial. Anesth Analg. 2011;112:804–812. (Among 619 women undergoing open abdominal surgery who received rolapitant [5, 20, 70 or 200 mg] or ondansetron or placebo, nausea and vomiting were less on the higher doses of rolapitant and ondansetron compared to placebo, yet adverse event rates were similar across all groups and "laboratory findings...were not significantly different when compared to placebo"). 21385988
Schwartzberg LS, Modiano MR, Rapoport BL, Chasen MR, Gridelli C, Urban L, Poma A, et al. Safety and efficacy of rolapitant for prevention of chemotherapy-induced nausea and vomiting after administration of moderately emetogenic chemotherapy or anthracycline and cyclophosphamide regimens in patients with cancer: a randomised, active-controlled, double-blind, phase 3 trial. Lancet Oncol. 2015;16:1071–1078. (Among 1369 patients receiving cyclic emetogenic cancer chemotherapy who received pretreatment with granisetron and dexamethasone with or without rolapitant, delayed phase nausea and vomiting were less with rolapitant while adverse event rates were similar in both groups, the most frequent being constipation, fatigue, dizziness and headache; no mention of ALT elevations or hepatotoxicity). 26272768
Rapoport BL, Chasen MR, Gridelli C, Urban L, Modiano MR, Schnadig ID, Poma A, et al. Safety and efficacy of rolapitant for prevention of chemotherapy-induced nausea and vomiting after administration of cisplatin-based highly emetogenic chemotherapy in patients with cancer: two randomised, active-controlled, double-blind, phase 3 trials. Lancet Oncol. 2015;16:1079–1089. (Among 1087 patients receiving cisplatin based cancer chemotherapy who received granisetron and dexamethasone with or without rolapitant [180 mg on day 1], delayed nausea and vomiting were less with rolapitant, and adverse events were uncommon and similar between the two groups; no mention of ALT elevations or hepatotoxicity). 26272769
Olver I. Role of rolapitant in chemotherapy-induced emesis. Lancet Oncol. 2015;16:1006–1007. (Commentary on results of the three large randomized controlled trials of rolapitant described by Schwartzberg [2015] and Rapoport [2015]). 26272772
Syed YY. Rolapitant: first global approval. Drugs. 2015;75:1941–1945. (Review of the problem of chemotherapy induced nausea and vomiting, the acute [<24 hours] and delayed [1-5 days] phases, the standard approach to therapy, as well as the pharmacology, clinical efficacy and toxicity of rolapitant). 26467681
Rapoport B, Schwartzberg L, Chasen M, Powers D, Arora S, Navari R, Schnadig I. Efficacy and safety of rolapitant for prevention of chemotherapy-induced nausea and vomiting over multiple cycles of moderately or highly emetogenic chemotherapy. Eur J Cancer. 2016;57:23–30. (Pooled analysis of efficacy and safety of rolapitant based on four large placebo controlled trials; mentions that adverse events rates were similar in rolapitant [5.5%] vs placebo [6.8%] arms and there were no treatment related deaths and no mention of ALT elevations or hepatotoxicity). 26851398
Rolapitant (Varubi) for prevention and delayed chemotherapy-induced nausea and vomiting. Med Lett Drugs Ther. 2016;58:17–18. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of rolapitant shortly after its approval in the US, mentions the more common adverse events including neutropenia, hiccups, decreased appetite and dizziness, but makes no mention of ALT elevations or hepatotoxicity). 26812124
Abdel-Rahman O, Fouad M. Rolapitant: a pooled analysis of its efficacy and safety in the prophylaxis of chemotherapy-induced nausea and vomiting. Future Oncol. 2016;12:871–879. (Among 2856 patients enrolled in 4 trials of rolapitant vs placebo for prevention of nausea and vomiting after cancer chemotherapy, rolapitant was associated with a higher rate of both early and late complete responses [no vomiting], no mention of ALT elevations or hepatotoxicity). 26806790
Barbour S, Smit T, Wang X, Powers D, Arora S, Kansra V, Aapro M, Herrstedt J. Integrated safety analysis of rolapitant with coadministered drugs from phase II/III trials: an assessment of CYP2D6 or BCRP inhibition by rolapitant. Ann Oncol. 2017;28:1268–1273. (Among 2595 patients treated with rolapitant vs placebo to prevent nausea and vomiting after emetogenic chemotherapy, there was no increase in adverse events in those concurrently receiving CYP2D6 substrates or CYP 3A4 inducers; provides data on fatigue, constipation, anorexia, alopecia, and febrile neutropenia, but not ALT elevations or hepatotoxicity). 28327932
IV aprepitant (Cinvanti) for chemotherapy-induced nausea and vomiting. Med Lett Drugs Ther. 2018;60:e200–e201. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of aprepitant, the first substance P inhibitor approved for prevention of nausea and vomiting after highly emetogenic chemotherapy; in discussing adverse events, does not mention ALT elevations or hepatotoxicity). 30653479
Wang X, Zhang ZY, Wang J, Powers D, Arora S, Lu S, Kansra V. Pharmacokinetics, safety, and tolerability of rolapitant administered intravenously following single ascending and multiple ascending doses in healthy subjects. Clin Pharmacol Drug Dev. 2019;8:160–171. (In two pharmacokinetic studies in healthy adults, ascending dose infusions of rolapitant were “safe and well tolerated” with only mild and transient adverse events of headache, drug mouth, and fatigue, while the calculated half-life of rolapitant ranged from 5 to 10 days; routine clinical laboratory results were obtained, but results were not reported). 29905976
Navari RM. The safety of rolapitant for the treatment of nausea and vomiting associated with chemotherapy. Expert Opin Drug Saf. 2019;18:1127–1132. (Review of the safety and efficacy of oral and intravenously administered NK1 antagonists used for the prevention of chemotherapy induced nausea and vomiting, mentions that the most common adverse events are headache, constipation, and fatigue, but are no more frequent with rolapitant than with placebo and that it has no evidence of clinically significant drug-drug interactions, but that intravenous formulations were withdrawn cause of hypersensitivity reactions that occur with all parenteral NK1 formulations though appear least frequent with fosnetupitant). 31622113

## OTHER REFERENCE LINKS

Recent References on Rolapitant: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Rolapitant+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Rolapitant: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rolapitant)